# Rituximab

## OVERVIEW

### Introduction

Rituximab is a chimeric mouse/human monoclonal antibody to CD20 a cell surface antigen found on pre-B and mature B lymphocytes and which is approved for use in non-Hodgkin lymphoma and chronic lymphocytic leukemia as well as in several autoimmune conditions, including rheumatoid arthritis and Wegener granulomatous. Rituximab has been linked to many cases of severe and even fatal liver injury as a result of reactivation of inactive or previously resolved hepatitis B.

### Background

Rituximab (ri tux’ i mab) is a human mouse chimeric monoclonal immunoglobulin G1 antibody to the cell surface antigen CD20 (also known as human B lymphocyte restricted differentiation antigen: Bp35) which is found on mature B cells as well as 90% of B cell neoplasms such as non-Hodgkin lymphoma and chronic lymphocytic leukemia. CD20 is not present on pro-B cells, hematopoietic stem cells, normal plasma cells or other normal lymphocytes, circulating cells or tissues. Engagement of rituximab with CD20 leads to B cell lysis and depletion of circulating and tissue B cells for an extended period, up to 6 to 8 months. There is an accompanying decrease in IgG and IgM levels, but in only 10% to 15% of patients do immunoglobulin levels fall below the normal range. Rituximab was approved for use in non-Hodgkin lymphoma and chronic lymphocyte leukemia in the United States in 1997, and indications were subsequently expanded to severe autoimmune conditions including refractory rheumatoid arthritis and Wegener granulomatosis (granulomatosis with polyangiitis). Rituximab is used off-label and is under active investigation in several other malignant conditions and autoimmune diseases. Rituximab is available in liquid solution in single use vials of 100 and 500 mg (10 mg/mL) under the brand name Rituxan. The dose and regimen varies by indication. Common side effects include infusion reactions, chills, fever, skin rash, fatigue, leukopenia and infections. Less common, but potentially severe side effects include cutaneous reactions (Stevens Johnson syndrome), infections, reactivation of tuberculosis, progressive multifocal leukoencephalopathy, cardiac arrhythmias, renal toxicity and bowel obstruction. Because of the potential severity of infusion reactions, premedication with antihistamines and acetaminophen is recommended and rituximab should be administered under close medical observation.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations are not uncommon (10% to 15%) during rituximab therapy, but are usually self-limited and resolve even with continuing cyclic therapy, and are no more common than with comparator chemotherapy arms without rituximab. In trials of rituximab in rheumatoid arthritis, serum ALT elevations were uncommon. Serum ALT elevations above 5 times the upper limit of normal (ULN) occur in 0.5% to 1.5% of patients, but clinically apparent liver injury during these episodes is rare. Few isolated case reports of clinically apparent, acute liver injury with symptoms or jaundice attributed to rituximab have been published. These have generally been marked by a rapid and abrupt onset of severe liver injury within days of starting rituximab. The association with administration of the monoclonal antibody is uncertain. The injury resembled acute hepatic necrosis as might occur with a direct toxin or with ischemia.

Rituximab is, however, a major cause of reactivation of hepatitis B which typically causes acute hepatocellular injury that can be severe and lead to acute liver failure and death or need for emergency liver transplantation. More than 100 cases of clinically apparent reactivation of hepatitis B attributed to rituximab have been reported in the literature, many of which have been severe or fatal. Reactivation can occur in patients who are HBsAg carriers and undergo chemotherapy with rituximab, but also in persons who have recovered from hepatitis B, who have no detectable HBsAg but have antibody to hepatitis B core antigen (anti-HBc) with or without antibody to HBsAg (anti-HBs) in serum. The onset of liver injury is delayed and may occur months after 3 to 6 courses of rituximab therapy. The usual sequence of events is appearance of rising levels of HBV DNA in serum shortly after rituximab is started, followed by rise in levels of HBsAg and HBeAg. When therapy is stopped and immune reconstitution has begun, serum ALT and AST levels start to rise followed by symptoms and jaundice. Reactivation of hepatitis B tends to be severe and the mortality rate in jaundiced cases exceeds 10%. Liver histology demonstrates an acute hepatitis-like pattern with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, which is compatible with an immune mediated hepatic injury. Restarting rituximab can result in recurrence of injury, although corticosteroid or antiviral treatment may block recurrence.

Reactivation of HBV in persons who have resolved hepatitis B (anti-HBc without HBsAg in serum) is usually referred to as “reverse seroconversion” and reactivation in persons with preexisting HBsAg in serum as “typical” HBV reactivation. The two forms of reactivation have somewhat different clinical, biochemical and virology courses. In general, patients with reverse seroconversion have received more rigorous immunosuppression, the latency until onset is longer, peak levels of HBV DNA are lower and the disease course is more severe in patients than in patients with typical reactivation. The time to appearance of clinically apparent reactivation tends to be 3 to 6 months in patients with typical reactivation, but 12 to 36 months in those with reverse seroconversion. Outcomes may also be different, reverse seroconversion tending to be more severe and more likely to resolve with disappearance of HBsAg than typical reactivation. Exceptions occur in both situations, however. Some patients with reverse seroconversion do not revert back to being HBsAg negative, particularly those who have had hematopoietic cell transplantation (HCT). In addition, some patients with classic reactivation of hepatitis B ultimately clear HBsAg as a result of the acute liver injury. Both forms of reactivation appear to be ameliorated by early intervention with oral antiviral therapy, but institution of therapy after appearance of clinical disease and jaundice may not be effective and many instances of fatal reactivation have occurred despite rapid institution of treatment with oral antiviral agents.

Finally, rituximab can reactivate other viral infections, and severe instances of acute hepatitis due to adenovirus, parvovirus and other opportunistic viral infections after rituximab therapy have been described.

Likelihood score: A (well known cause of reactivation of hepatitis B and rare cause of immune mediated, clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury in reactivation of hepatitis B appears to be a brisk immunological response to rising levels of viral antigens on hepatocytes. Injury often arises after rituximab therapy has stopped or between courses of treatment.

### Outcome and Management

Guidelines for management of patients who are to receive rituximab recommend routine screening for hepatitis B before starting treatment. Screening should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). Prophylaxis with a potent oral, antiviral agent effective against hepatitis B is recommended for all persons who have HBsAg in serum and is suggested for those with anti-HBc without HBsAg. An alternative approach is monthly monitoring for HBV DNA during therapy and early institution of antiviral therapy if levels rise. This approach, however, is problematic in that reactivation may occur late during chemotherapy or even after it is completed. The choice of antiviral agents includes lamivudine, telbivudine, adefovir, tenofovir or entecavir. All are given once a day and are extremely well tolerated. Lamivudine is less expensive than the other agents, but is associated with a high rate of antiviral resistance, particularly if given for more than 6 months. Tenofovir and entecavir are the most potent and have high barriers to antiviral resistance, which is important if long term therapy is planned. However, there are no prospectively acquired controlled studies to support use of one of these agents over another. Finally, the appropriate duration of treatment is unclear. The typical recommendation is to continue antivirals for at least 6 months after stopping cancer chemotherapy, but cases of reactivation following withdrawal of antiviral therapy many months after stopping chemotherapy (including fatal instances) have been described. For these reasons, monitoring during withdrawal of antiviral therapy is appropriate. In patients with anti-HBc without HBsAg, boosting titers of anti-HBs before or in-between treatment courses may be helpful in preventing reactivation. However, patients with lymphoma or autoimmune conditions and those who are receiving rituximab generally have poor responses to vaccination and this approach has not been critically evaluated in prospective controlled studies.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies; Antirheumatic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rituximab – Rituxan®

DRUG CLASS

Antineoplastic Agents

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Rituximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Rituximab | 174722-31-7 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 18 June 2018

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Yeo W, Chan PK, Zhong S, Ho WM, Steinberg JL, Tam JS, Hui P, et al. Frequency of hepatitis B virus reactivation in cancer patients undergoing cytotoxic chemotherapy: a prospective study of 626 patients with identification of risk factors. J Med Virol 2000; 62: 299-307. (Among 71 Chinese patients with HBsAg who underwent cancer chemotherapy [not with rituximab] for various malignancies, 15 developed reactivation of HBV including 6 with jaundice and 3 with acute liver failure, but none died). 11055239
Ng HJ, Lim LC. Fulminant hepatitis B virus reactivation with concomitant listeriosis after fludarabine and rituximab therapy: case report. Ann Hematol 2001; 80: 549-52. (53 year old woman with acute leukemia and HBsAg developed reactivation of HBV 3 months after completing 4 monthly courses of rituximab [bilirubin 10.8 mg/dL, ALT 1479 U/L, HBV DNA present], dying 12 days later with progressive hepatic failure and sepsis). 11669307
Dervite I, Hober D, Morel P. Acute hepatitis B in a patient with antibodies to hepatitis B surface antigen who was receiving rituximab. N Engl J Med 2001; 344: 68-9. (69 year old man with lymphoma who had anti-HBc without HBsAg in serum developed jaundice 6 months after 4 weekly infusions of rituximab [HBsAg, IgM anti-HBc and HBV DNA positive, no liver tests provided], recovering thereafter, but remaining HBsAg positive). 11187122
Coiffier B, Lepage E, Briere J, Herbrecht R, Tilly H, Bouabdallah R, Morel P, et al. CHOP chemotherapy plus rituximab compared with CHOP alone in elderly patients with diffuse large-B-cell lymphoma. N Engl J Med 2002; 346: 235-42. (Among 399 patients with diffuse large cell lymphoma treated with 8 cycles of either CHOP or CHOP-rituximab, remission rates and survival were greater, but "clinically relevant toxicity was not significantly greater" with rituximab; grade 3 or 4 liver toxicity occurring in 1.5% [rituximab] vs 2.5% and no deaths occurred from liver failure). 11807147
Kami M, Hamaki T, Murashige N, Kishi Y, Kusumi E, Yuji K, Miyakoshi S, et al. Safety of rituximab in lymphoma patients with hepatitis B or hepatitis C virus infection. Hematol J 2003; 4: 159-62. (Among 5 patients with HBsAg and non-Hodgkin lymphoma treated with rituximab and given lamivudine prophylaxis, none developed reactivation of HBV; among 3 patients with HCV infection and lymphoma receiving rituximab, none developed a flare of disease during or after treatment). 12750737
Westhoff TH, Jochimsen F, Schmittel A, Stoffler-Meilicke M, Schafer JH, Zidek W, Gerlich WH, et al. Fatal hepatitis B virus reactivation by an escape mutant following rituximab therapy. Blood 2003; 102: 1930. (71 year old man with lymphoma and anti-HBc and anti-HBs without HBsAg developed jaundice 3 months after starting rituximab therapy [HBsAg and HBV DNA positive], dying of hepatic failure 19 days after presentation). 12930732
Tsutsumi Y, Kawamura T, Saitoh S, Yamada M, Obara S, Miura T, Kanamori H, et al. Hepatitis B virus reactivation in a case of non-Hodgkin's lymphoma treated with chemotherapy and rituximab: necessity of prophylaxis for hepatitis B virus reactivation in rituximab therapy. Leuk Lymphoma 2004; 45: 627-9. (68 year old woman with non-Hodgkin lymphoma and HBsAg developed reactivation of HBV and hepatic failure 3-4 weeks after a fourth course of rituximab, cyclophosphamide, doxorubicin and vincristine [bilirubin not given, ALT ~1800 U/L], resolving with lamivudine therapy). 15160930
Edwards JC, Szczepanski L, Szechinski J, Filipowicz-Sosnowska A, Emery P, Close DR, Stevens RM, et al. Efficacy of B-cell-targeted therapy with rituximab in patients with rheumatoid arthritis. N Engl J Med 2004; 350: 2572-81. (Among 161 patients with rheumatoid arthritis treated with rituximab with methotrexate or cyclophosphamide versus methotrexate alone, side effects included infusion reactions and infections, no mention of ALT levels or clinically apparent liver injury). 15201414
Sarrecchia C, Cappelli A, Aiello P. HBV reactivation with fatal fulminating hepatitis during rituximab treatment in a subject negative for HBsAg and positive for HBsAb and HBcAb. J Infect Chemother 2005; 11: 189-91. (53 year old man with CLL and anti-HBc and anti-HBs without HBsAg developed reactivation of HBV after 3 monthly infusions of rituximab [bilirubin 17.1 mg/dL, ALT 2120 U/L, HBV DNA positive], with progressive liver failure and death within 27 days). 16133710
Law JK, Ho JK, Hoskins PJ, Erb SR, Steinbrecher UP, Yoshida EM. Fatal reactivation of hepatitis B post-chemotherapy for lymphoma in a hepatitis B surface antigen-negative, hepatitis B core antibody-positive patient: potential implications for future prophylaxis recommendations. Leuk Lymphoma 2005; 46: 1085-9. (67 year old Korean man with B cell lymphoma and anti-HBc without HBsAg developed reactivation of HBV 3 weeks after completing a course of CHOP-rituximab, progressing to hepatic failure [HBsAg positive, bilirubin not given, ALT 2204 U/L, INR 2.8 rising to 7.5] and dying within 10 days of admission despite lamivudine therapy). 16019563
Niscola P, Del Principe MI, Maurillo L, Venditti A, Buccisano F, Piccioni D, Amadori S, Del Poeta G. Fulminant B hepatitis in a surface antigen-negative patient with B-cell chronic lymphocytic leukaemia after rituximab therapy. Leukemia 2005; 19: 1840-1. (51 year old man with CLL and anti-HBc without HBsAg developed reactivation of hepatitis B after 6 monthly courses of rituximab, becoming HBV DNA positive, but without a period of HBsAg detectability and progressive liver failure and death). 16094417
Qazilbash MH, Qu Z, Hosing C, Couriel D, Donato M, Giralt S, Champlin R. Rituximab-induced acute liver failure after an allogeneic transplantation for chronic myeloid leukemia. Am J Hematol 2005; 80: 43-5. (21 year old woman with chronic myelogenous leukemia underwent bone marrow transplantation and was then treated with rituximab for autoimmune hemolytic anemia and developed jaundice 3 days later [bilirubin 20.5 rising to 62 mg/dL, ALT >2000 U/L, with progressive liver failure and death within 3 days; timing makes it unlikely to have been due to rituximab). 16138357
Ozgönenel B, Moonka D, Savaşan S. Fulminant hepatitis B following rituximab therapy in a patient with Evans syndrome and large B-cell lymphoma. Am J Hematol 2006; 81: 302. (21 year old man with non-Hodgkin lymphoma with unknown HBV status developed reactivation of HBV within a few weeks of completing 3 courses of CHOP-rituximab [HBsAg positive, IgM anti-HBc negative, HBV DNA >200 million copies/mL, no liver test results given], and died within 15 days of admission despite lamivudine therapy). 16550511
Iyer A, Mathur R, Deepak BV, Sinard J. Fatal adenoviral hepatitis after rituximab therapy. Arch Pathol Lab Med 2006; 130: 1557-60. (60 year old man with Waldenstrom macroglobulinemia developed cough and fever after a third course of rituximab and pneumonitis, progressing to multiorgan failure and death with marked elevations in liver enzymes shortly before [ALT 8408 U/L, bilirubin not given], autopsy showing adenoviral pneumonia and hepatitis). 17090202
Sera T, Hiasa Y, Michitaka K, Konishi I, Matsuura K, Tokumoto Y, Matsuura B, et al. Anti-HBs-positive liver failure due to hepatitis B virus reactivation induced by rituximab. Intern Med 2006; 45: 721-4. (59 year old man with lymphoma and anti-HBc without HBsAg developed reactivation of HBV shortly after a third course of rituximab [bilirubin 26.4 mg/dL, ALT 359 U/L, GTP 199 U/L, HBsAg positive, HBV DNA ~9 million copies/mL], with progressive liver failure and death 3-4 months later). 16819252
Klepfish A, Rachmilevitch E, Schattner A. Parvovirus B19 reactivation presenting as neutropenia after rituximab treatment. Eur J Intern Med 2006; 17: 505-7. (58 year old woman with primary biliary cirrhosis and thrombocytopenic purpura developed neutropenia 4 months after 4 weekly infusions of rituximab and was found to have parvovirus B19 IgM and IgG antibody; no mention of liver test results). 17098597
Yamagata M, Murohisa T, Tsuchida K, Okamoto Y, Tsunoda S, Nakamura M, Kusano K, et al. Fulminant B hepatitis in a surface antigen and hepatitis B DNA-negative patient with diffuse large B-cell lymphoma after CHOP chemotherapy plus rituximab. Leuk Lymphoma. 2007; 48: 431-3. (54 year old man with diffuse large cell lymphoma and anti-HBc without HBsAg in serum developed rising titers of HBV DNA one month after finishing a 7 month course of monthly CHOP-rituximab, followed 3 months later by acute hepatitis, progressive liver failure and death). 17325912
Ono K, Iyama S, Matsunaga T, Sato T, Sato Y, Okuda T, Takada K, et al. [Reactivation of hepatitis B virus due to rituximab plus CHOP after preemptive lamivudine administration in a patient with diffuse large B-cell lymphoma]. Gan To Kagaku Ryoho 2007; 34: 1509-12. Japanese. (59 year old woman with B-cell lymphoma developed reactivation of HBV 2 months after stopping lamivudine which had been given during and for 3 months after CHOP-rituximab therapy, resolving with restarting lamivudine and adding interferon beta). 17876158
Yang SH, Kuo SH. Reactivation of hepatitis B virus during rituximab treatment of a patient with follicular lymphoma. Ann Hematol 2008; 87: 325-7. (41 year old woman with lymphoma and HBsAg had reactivation of HBV after 4 months of chlorambucil [bilirubin 1.2 mg/dL, ALT 1698 U/L, HBV DNA 40 million copies/mL], which responded to lamivudine therapy, but recurred when she was treated with rituximab without lamivudine [bilirubin 1.7 mg/dL, ALT 819 U/L, HBV DNA 228 million copies/mL], resolving again after restarting lamivudine). 17932671
Dillon R, Hirschfield GM, Allison ME, Rege KP. Fatal reactivation of hepatitis B after chemotherapy for lymphoma. BMJ 2008; 337: a423. (21 year old woman with B cell lymphoma and unknown HBV status developed HBV reactivation 2 weeks after a 4th cycle of CHOP-rituximab [liver tests not given, HBsAg positive, IgM anti-HBc negative, HBV DNA 450 million IU/mL], with progressive liver failure and death). 18595895
Garcia-Rodriguez MJ, Canales MA, Hernandez-Maraver D, Hernandez-Navarro F. Late reactivation of resolved hepatitis B virus infection: an increasing complication post rituximab-based regimens treatment? Am J Hematol 2008; 83: 673-5. (53 and 68 year old women with lymphoma and resolved hepatitis B treated with CHOP-rituximab developed reactivation 9 months and 1 year after completing therapy, one dying of acute liver failure and one recovering on lamivudine followed by entecavir therapy). 18528824
Targhetta C, Cabras MG, Mamusa AM, Mascia G, Angelucci E. Hepatitis B virus-related liver disease in isolated anti-hepatitis B-core positive lymphoma patients receiving chemo- or chemo-immune therapy. Haematologica 2008; 93: 951-2. (Among 395 patients with non-Hodgkin lymphoma and anti-HBc without HBsAg in serum who were treated with chemotherapy between 1989 and 2006, 4 developed clinically apparent reactivation of hepatitis B including 0.8% treated with chemotherapy only and 2.7% given rituximab; while all 4 recovered clinically, all remained HBsAg positive in follow up). 18515881
Wasmuth JC, Fischer HP, Sauerbruch T, Dumoulin FL. Fatal acute liver failure due to reactivation of hepatitis B following treatment with fludarabine, cyclophosphamide and rituximab for low grade non-Hodgkin's lymphoma. Eur J Med Res 2008; 13: 483-6. (Abstract: Patient developed reactivation of hepatitis B after 6th cycle of rituximab with fludarabine and cyclophosphamide). 19008178
Sanchez MJ, Buti M, Homs M, Palacios A, Rodriguez-Frias F, Esteban R. Successful use of entecavir for a severe case of reactivation of hepatitis B virus following polychemotherapy containing rituximab. J Hepatol 2009; 51: 1091-6. (62 year old man with CLL and anti-HBc without HBsAg in serum developed reactivation of HBV 4 weeks after a 4th cycle of rituximab based chemotherapy [bilirubin rising to 10.3 mg/dL, ALT 3481 U/L, INR 1.8, HBV DNA ~80 million IU/mL] treated with entecavir and recovered, but remained HBsAg positive). 19836097
Takahashi T, Koike T, Hashimoto S, Miura T, Nakamura J, Yamada S, Miura T, et al. A case of lamivudine-sensitive de novo acute hepatitis B induced by rituximab with the CHOP regimen for diffuse large B cell lymphoma. Hepatol Int 2009; 3: 316-22. (57 year old HBsAg-negative woman with B cell lymphoma developed HBsAg and hepatitis after 12 courses of CHOP-rituximab [bilirubin 0.5 mg/dL, ALT 1113 U/L, Alk P 423 U/L, HBV DNA ~50 million copies/mL], recovering on lamivudine therapy, but remaining HBsAg positive). 19669383
Fukushima N, Mizuta T, Tanaka M, Yokoo M, Ide M, Hisatomi T, Kuwahara N, et al. Retrospective and prospective studies of hepatitis B virus reactivation in malignant lymphoma with occult HBV carrier. Ann Oncol 2009; 20: 2013-7. (Among 24 patients with anti-HBc without HBsAg in serum who were monitored during treatment with chemotherapy, 2 developed rising HBV DNA levels [one after HCT and one after rituximab therapy] and were promptly treated with entecavir, both with rapid resolution). 19561036
Stange MA, Tutarel O, Pischke S, Schneider A, Strassburg CP, Becker T, Barg-Hock H, et al. Fulminant hepatic failure due to chemotherapy-induced hepatitis B reactivation: role of rituximab. Z Gastroenterol 2010; 48: 258-63. (62 and 53 year old men with lymphoma developed reactivation of HBV after 4 and 6 courses of rituximab based chemotherapy, one undergoing liver transplant and one dying after attempts at hepatocyte transplantation; prestatus unknown, but both were HBsAg positive, IgM anti-HBc negative). 20127601
Artz AS, Somerfield MR, Feld JJ, Giusti AF, Kramer BS, Sabichi AL, Zon RT, et al. American Society of Clinical Oncology provisional clinical opinion: chronic hepatitis B virus infection screening in patients receiving cytotoxic chemotherapy for treatment of malignant diseases. J Clin Oncol 2010; 28: 3199-202. (Statement from the American Society of Clinical Oncology that there is inadequate medical evidence to recommend routine screening for HBV markers in patients scheduled for cancer chemotherapy, but that "ASCO assumes no responsibility for any injury or damage to persons or property arising out of use" of ASCO clinical opinions). 20516452
Li X, Lin Q, Dong M, Wen JY, Wei L, Ma XK, Chen ZH, et al. Prognostic analysis of acute exacerbations of hepatitis-B after chemotherapy in combination with rituximab in 19 patients with lymphoma. Leuk Lymphoma 2010; 51: 1678-85. (Among 19 Chinese patients with reactivation of HBV after rituximab therapy, 9 died; factors predicting poor outcome included INR, total bilirubin and shorter time between last rituximab course and onset). 20807095
Del Prete CJ, Cohen NS. A case of rituximab-induced hepatitis. Cancer Biother Radiopharm 2010; 25: 747-8. (38 year old man with ITP developed fever and jaundice after third dose of rituximab [bilirubin 12 mg/dL, ALT 256 U/L, Alk P 313 U/L, HBV markers negative], with rapid resolution on stopping rituximab). 21204770
Zhang B, Wang J, Xu W, Wang L, Ni W. Fatal reactivation of occult hepatitis B virus infection after rituximab and chemotherapy in lymphoma: necessity of antiviral prophylaxis. Onkologie 2010; 33: 537-9. (50 year old man with B cell lymphoma developed jaundice 10 days after the 4th course of CHOP-rituximab [bilirubin ~8.0 rising to 45 mg/dL, ALT ~2500 U/L, HBsAg and HBV DNA present], dying of liver failure despite entecavir treatment and liver transplantation). 20926902
Villadolid J, Laplant KD, Markham MJ, Nelson DR, George TJ Jr. Hepatitis B reactivation and rituximab in the oncology practice. Oncologist 2010; 15: 1113-21. (Review of the frequency, cause and management of reactivation of hepatitis B). 20930099
Chung SM, Sohn JH, Kim TY, Yoo KD, Ahn YW, Bae JH, Jeon YC, et al. [Fulminant hepatic failure with hepatitis B virus reactivation after rituximab treatment in a patient with resolved hepatitis B]. Korean J Gastroenterol 2010; 55: 266-9. Korean. (Four anti-HBc-positive, HBsAg-negative Korean patients with lymphoma treated with rituximab based chemotherapy developed reactivation of hepatitis B with reappearance of HBsAg and high levels of HBV DNA, one of whom died of acute liver failure). 20389182
Muñoz Bertrán E, Pérez Ceballos E, Gómez Espín R, Ortega González I. [Hepatitis B reactivation in an HbsAg-negative/anti-HBc-positive patient with B-cell non-Hodgkin lymphoma receiving chemotherapy with rituximab]. Gastroenterol Hepatol 2010; 33: 377-81. Spanish. (81 year old man with non-Hodgkin lymphoma and anti-HBc without HBsAg in serum developed reactivation of hepatitis B five months after starting rituximab based chemotherapy [bilirubin 2.2 mg/dL, ALT 551 U/L, Alk P 1,146 U/L, HBsAg and HBV DNA positive], with progressive liver failure and death). 20363054
Méndez-Navarro J, Corey KE, Zheng H, Barlow LL, Jang JY, Lin W, Zhao H, et al. Hepatitis B screening, prophylaxis and re-activation in the era of rituximab-based chemotherapy. Liver Int 2011; 31: 330-9. (Among 1429 patients who received rituximab for non-Hodgkin lymphoma, screening for HBV status was done in 524 [37%], 20 of whom had HBsAg and 10 had HBV reactivation; among patients who were not screened, 5 developed clinically apparent reactivation and one died of acute liver failure). 20738779
Zachou K, Dalekos GN. Hepatitis B re-activation with rituximab therapy: treat the patient not the disease. Liver Int 2011; 31: 277-9. (Editorial in response to Mendez-Navarro [2011] on need to screen for HBV markers in patients who are to receive rituximab both as cancer chemotherapy and for autoimmune conditions). 21281426
Oketani M, Ido A, Tsubouchi H. Changing etiologies and outcomes of acute liver failure: A perspective from Japan. J Gastroenterol Hepatol 2011; 26 Suppl 1: 65-71. (Analysis of from multicenter study in Japan lists reactivation of HBV as an increasing cause of acute liver failure). 21199516
Watanabe M, Shibuya A, Tsunoda Y, Danbara M, Ishii R, Ohsaka M, Takada J, et al. Re-appearance of hepatitis B virus following therapy with rituximab for lymphoma is not rare in Japanese patients with past hepatitis B virus infection. Liver Int 2011; 31: 340-7. (In a retrospective analysis of 45 patients with lymphoma and anti-HBc without HBsAg in serum who underwent chemotherapy, 5 of 24 [21%] who received rituximab, but none of 21 who did not, developed HBV DNA during or following chemotherapy ). 21134110
Nooka A, Shenoy PJ, Sinha R, Lonial S, Flowers CR. Hepatitis C reactivation in patients who have diffuse large B-cell lymphoma treated with rituximab: a case report and review of literature. Clin Lymphoma Myeloma Leuk 2011; 11: 379-84. (52 year old man with lymphoma and chronic hepatitis C had slight elevations in HCV RNA levels without change in serum enzymes or liver injury during or after CHOP-rituximab therapy). 21729690
Mastroianni CM, Lichtner M, Citton R, Del Borgo C, Rago A, Martini H, Cimino G et al. Current trends in management of hepatitis B virus reactivation in the biologic therapy era. World J Gastroenterol 2011; 17: 3881-7. (Review of the cause and risk factors for reactivation of HBV, the role of rituximab and preventive strategies). 22025876
Cheung WI, Lin SY, Leung VK, Fung KS, Lam YK, Lo FH, Chau TN. Prospective evaluation of seropositive occult hepatitis B viral infection in lymphoma patients receiving chemotherapy. Hong Kong Med J 2011; 17: 376-80. (Among 47 Chinese patients with lymphoma given chemotherapy during a 1 year period, 10 [21%] had anti-HBc without HBsAg in serum of whom one developed reactivation of HBV 32 weeks after starting rituximab based therapy [bilirubin normal, ALT 1430 U/L, HBV DNA 2 million IU/mL, HBeAg positive but HBsAg negative], resolving rapidly with entecavir therapy). 21979474
Coppola N, Tonziello G, Pisaturo M, Messina V, Guastafierro S, Fiore M, Iodice V, et al. Reactivation of overt and occult hepatitis B infection in various immunosuppressive settings. J Med Virol 2011; 83: 1909-16. (Among 23 Italian patients with symptomatic reactivation of HBV, the 13 who had anti-HBc without HBsAg before therapy had lower peak HBV DNA levels and were more likely to have malignant disease and receive rituximab than the 10 who were HBsAg positive before therapy). 21915865
Lock G, Helmich F, Bertram M. [Impending liver failure after chemoimmunotherapy-induced reactivation of hepatitis B - successful treatment with entecavir]. Dtsch Med Wochenschr 2012; 137: 1248-50. German. (83 year old woman with leukemia developed reactivation of HBV 2 weeks after a 6th cycle of rituximab and bendamustine [bilirubin 27.8 mg/dL, ALT 1353, INR 1.68, HBsAg, HBeAg and HBV DNA present], resolving with entecavir therapy and HBsAg became negative 8 months later). 22644491
Sagnelli E, Pisaturo M, Sagnelli C, Coppola N. Rituximab-based treatment, HCV replication, and hepatic flares. Clin Dev Immunol 2012; 2012: 945950. (Review of literature on effects of rituximab therapy on HCV replication identified 5 studies in 59 patients found that rises in HCV RNA levels during therapy are common [~95%] and flares of disease can occur [~40%] that rarely may be severe). 22919406
Hwang JP, Vierling JM, Zelenetz AD, Lackey SC, Loomba R. Hepatitis B virus management to prevent reactivation after chemotherapy: a review. Support Care Cancer 2012; 20: 2999-3008. (Review of reactivation of HBV from chemotherapy stresses need for routine screening for HBV markers particularly for patients who are to receive rituximab). 22933131
Mahale P, Kontoyiannis DP, Chemaly RF, Jiang Y, Hwang JP, Davila M, Torres HA. Acute exacerbation and reactivation of chronic hepatitis C virus infection in cancer patients. J Hepatol 2012; 57: 1177-85. (Retrospective analysis of 308 patients with chronic hepatitis C who received cancer chemotherapy found acute exacerbations of disease [greater than 3 fold increase in ALT] in 33 [11%], higher risk was associated with rituximab therapy and hematologic malignancy; none of 32 patients with anti-HCV without HCV RNA developed evidence of reactivation). 22871500
Keystone EC, Cohen SB, Emery P, Kremer JM, Dougados M, Loveless JE, Chung C, et al. Multiple courses of rituximab produce sustained clinical and radiographic efficacy and safety in patients with rheumatoid arthritis and an inadequate response to 1 or more tumor necrosis factor inhibitors: 5-year data from the REFLEX study. J Rheumatol 2012; 39: 2238-46. (Among 480 patients with rheumatoid arthritis treated in an open label study of rituximab for up to 5 years, adverse events were most frequent during the first year and stable thereafter; there were no cases of reactivation of HBV and no mention of ALT elevations or hepatotoxicity). 23027887
Pyrpasopoulou A, Douma S, Vassiliadis T, Chatzimichailidou S, Triantafyllou A, Aslanidis S. Reactivation of chronic hepatitis B virus infection following rituximab administration for rheumatoid arthritis. Rheumatol Int 2011; 31: 403-4. (56 year old woman with rheumatoid arthritis and HBsAg but low levels of HBV DNA in serum developed fever and raised serum enzymes one month after starting rituximab infusions [bilirubin normal, ALT 150 U/L, HBV DNA 100 million IU/mL], resolving with tenofovir therapy). 19830433
Andres M, Courtney P. No hepatitis B reactivation in a patient with refractory antisynthetase syndrome successfully treated with rituximab. Joint Bone Spine 2011; 78: 653-4. (46 year old HBsAg-positive man with antisynthetase syndrome was successfully treated with rituximab and given prophylaxis with lamivudine and did not develop reactivation of the underlying hepatitis B). 21807545
Ferreira R, Carvalheiro J, Torres J, Fernandes A, Giestas S, Mendes S, Agostinho C, et al. Fatal hepatitis B reactivation treated with entecavir in an isolated anti-HBs positive lymphoma patient: a case report and literature review. Saudi J Gastroenterol 2012; 18: 277-81. (78 year old woman with non-Hodgkin lymphoma and anti-HBc and anti-HBs without HBsAg in serum developed severe reactivation of HBV 40 days after finishing 4th course of chemotherapy [bilirubin 21.6 mg/dL, ALT 2935 U/L, HBsAg and IgM anti-HBc positive, HBV DNA 2400 IU/mL, INR 1.66], dying of liver failure 27 days after presentation despite entecavir therapy). 22824772
Fylaktou A, Daoudaki M, Dimou V, Sianou E, Papaventsis D, Mavrovouniotis I, Fouzas I, et al. Hepatitis B reactivation in a renal transplant patient due to a surface antigen mutant strain: a case report. Transplant Proc 2012; 44: 2773-5. (52 year old man with HBsAg in serum underwent renal transplantation and developed reactivation of HBV 4 months later after one dose of rituximab and while on cyclosporine, mycophenolate, and prednisone [ALT 92 U/L, HBV DNA 2 million IU/mL, HBsAg, HBeAg], no mention of recovery). 23146520
Pei SN, Ma MC, Wang MC, Kuo CY, Rau KM, Su CY, Chen CH. Analysis of hepatitis B surface antibody titers in B cell lymphoma patients after rituximab therapy. Ann Hematol 2012; 91: 1007-12. (Among 29 patients with B cell lymphomas who had anti-HBs without HBsAg in serum, anti-HBs and total IgG levels decreased with rituximab and 8 patients became anti-HBs negative, all of whom had low levels before therapy; 1 patient developed HBV reactivation and died of acute liver failure). 22273839
Ceccarelli L, Salpini R, Sarmati L, Svicher V, Bertoli A, Sordillo P, et al. Late hepatitis B virus reactivation after lamivudine prophylaxis interruption in an anti-HBs-positive and anti-HBc-negative patient treated with rituximab-containing therapy. J Infect 2012; 65: 180-3. (72 year old woman with B cell lymphoma and anti-HBs without anti-HBc or HBsAg in serum developed reactivation of HBV 18 months after finishing rituximab based chemotherapy and 12 months after stopping lamivudine [bilirubin 7.2 mg/dL, ALT 1904 U/L, HBV DNA 231,000 IU/mL], with no mention of recovery or follow up). 22138369
Ghrénassia E, Mékinian A, Rouaghe S, Ganne N, Fain O. Reactivation of resolved hepatitis B during rituximab therapy for rheumatoid arthritis. Joint Bone Spine 2012; 79: 100-1. (78 year old man with rheumatoid arthritis and resolved hepatitis B developed reactivation of HBV 3 months after 4th 6-month course of rituximab [bilirubin not given, ALT 421 U/L, Alk P 87 U/L, HBsAg, HBeAg and HBV DNA present], resolving on entecavir therapy). 21944979
Papamichalis P, Alexiou A, Boulbou M, Dalekos GN, Rigopoulou EI. Reactivation of resolved hepatitis B virus infection after immunosuppression: is it time to adopt pre-emptive therapy? Clin Res Hepatol Gastroenterol 2012; 36: 84-93. (68 year old man and 75 year old woman with lymphoma had anti-HBc without HBsAg before chemotherapy and were found to have serum ALT elevations, HBsAg and HBV DNA in serum after rituximab therapy). 21920838
Francisci D, Falcinelli F, Schiaroli E, Capponi M, Belfiori B, Cecchini E, Baldelli F. Reactivation of hepatitis B virus replication due to cytotoxic therapy: a five-year prospective study. Tumori 2012; 98: 220-4. (Among 478 Italian patients with hematological malignancies undergoing cancer chemotherapy, 75 had anti-HBc without HBsAg in serum of whom 5 [7%] developed reactivation of HBV with reappearance of HBsAg in serum, all responding to antiviral therapy and none died). 22677988
Latus J, Klein R, Koetter I, Schwab M, Fritz P, Kimmel M, Alscher MD, et al. Cholestatic liver disease after rituximab and adalimumab and the possible role of cross-reacting antibodies to Fab 2 fragments. PLoS One 2013; 8: e78856. (Analysis of serum samples from unclear number of patients with liver injury on adalimumab or rituximab identified cross reacting antibodies to Fab 2 fragments). 24244376
Sperl J, Frankova S, Kieslichova E, Oliverius M, Janousek L, Honsova E, Trunecka P, et al. Urgent liver transplantation for chemotherapy-induced HBV reactivation: a suitable option in patients recently treated for malignant lymphoma. Transplant Proc 2013; 45: 2834-7. (Three cases, 2 men and 1 woman, ages 42-49 years, with lymphoma developed reactivation of HBV after 8-13 cycles of rituximab therapy [bilirubin 21-35 mg/dL, ALT 2340-3000 U/L, HBsAg and high levels of HBV DNA in serum], all undergoing urgent liver transplantation with long term survival, tumor free and HBsAg negative on HBIG and oral antiviral therapy). 24034061
Yang JD, Girotra M, Vaid A, Duarte-Rojo A. Hepatitis B reactivation in patient with non-Hodgkin's lymphoma receiving rituximab-based chemotherapy: need for education and attention. J Ark Med Soc 2013; 110: 110-2. (Abstract: 58 year old man with lymphoma and chronic hepatitis B developed severe reactivation while receiving rituximab). 24367885
Tsutsumi Y, Yamamoto Y, Shimono J, Ohhigashi H, Teshima T. Hepatitis B virus reactivation with rituximab-containing regimen. World J Hepatol 2013; 5: 612-20. (Review of reactivation of hepatitis B with rituximab-containing chemotherapy). 24303089
van Vollenhoven RF, Emery P, Bingham CO 3rd, Keystone EC, Fleischmann RM, Furst DE, Tyson N, et al. Long-term safety of rituximab in rheumatoid arthritis: 9.5-year follow-up of the global clinical trial programme with a focus on adverse events of interest in RA patients. Ann Rheum Dis 2013; 72: 1496-502. (Among 3194 patients with rheumatoid arthritis followed in a global clinical trial program for up to 9.5 years, rates of serious adverse events and infections were stable over time and similar to comparator arms; there were no cases of HBV reactivation and no mention of hepatotoxicity). 23136242
Mitka M. FDA: Increased HBV reactivation risk with ofatumumab or rituximab. JAMA 2013; 310: 1664. (News report of the FDA alert to physicians of the high risk of HBV reactivation in patients receiving ofatumumab and rituximab). 24150447
Hsu C, Tsou HH, Lin SJ, Wang MC, Yao M, Hwang WL, Kao WY, et al.; on behalf of the Taiwan Cooperative Oncology Group. Chemotherapy-induced hepatitis B reactivation in lymphoma patients with resolved HBV infection: A prospective study. Hepatology 2014; 59: 2092-100. (Among 150 patients with non-Hodgkin lymphoma who had anti-HBc without HBsAg in serum and were treated with rituximab containing regimens without prophylaxis and followed with monthly testing for HBV DNA, 27 [18%] developed HBV reactivation 3-57 weeks after starting chemotherapy [6 after stopping], 12 developed HBsAg, 7 HBeAg and 10 ALT elevations despite prompt therapy with entecavir, but none had acute liver failure or died). 24002804
Kusumoto S, Tanaka Y, Mizokami M, Ueda R. Strategy for preventing hepatitis B reactivation in patients with resolved HBV infection following rituximab-containing chemotherapy. Hepatology 2014; 60: 765-6. (Letter in response to Hsu [2013] stressing shortcomings of prospective monitoring for HBV DNA). 24347499
Gigi E, Georgiou T, Mougiou D, Boura P, Raptopoulou-Gigi M. Hepatitis B reactivation in a patient with rheumatoid arthritis with antibodies to hepatitis B surface antigen treated with rituximab. Hippokratia 2013; 17: 91-3. (64 year old woman with resolved hepatitis B and rheumatoid arthritis developed reactivation of HBV 2 years after starting rituximab and methotrexate [bilirubin not given, ALT 605 U/L, GGT 154 U/L, HBsAg and HBeAg positive despite presence of anti-HBs], with rapid loss of HBsAg and resolution of enzyme elevations within 6 months of stopping chemotherapy and starting entecavir). 23935355
Matsui T, Kang JH, Nojima M, Tomonari A, Aoki H, Yamazaki H, Yane K, et al. Reactivation of hepatitis B virus in patients with undetectable HBsAg undergoing chemotherapy for malignant lymphoma or multiple myeloma. J Med Virol 2013; 85: 1900-6. (Among 109 Japanese patients who were HBsAg negative and underwent chemotherapy for malignancy and were followed with monthly testing for HBV DNA, 4 of 59 [7%] with anti-HBc, but no other patient developed HBV reactivation, all 4 received rituximab and corticosteroids, during chemotherapy in 3 and afterwards in 1, none developed HBsAg or ALT elevations and all recovered, 2 with entecavir therapy). 23926082
Kim SJ, Hsu C, Song YQ, Tay K, Hong XN, Cao J, Kim JS, et al. Hepatitis B virus reactivation in B-cell lymphoma patients treated with rituximab: analysis from the Asia Lymphoma Study Group. Eur J Cancer 2013; 49: 3486-96. (Retrospective analysis of rates of HBV reaction in 340 patients with lymphoma receiving rituximab based chemotherapy identified HBV reactivation in 45 of 162 [28%] of HBsAg positive and 10% of HBsAg negative, but anti-HBc positive patients, risk factors being lack of antiviral prophylaxis and absence of anti-HBs and failures of prophylaxis being mostly due to lamivudine rather than entecavir). 23910494
Zachou K, Sarantopoulos A, Gatselis NK, Vassiliadis T, Gabeta S, Stefos A, Saitis A, et al. Hepatitis B virus reactivation in hepatitis B virus surface antigen negative patients receiving immunosuppression: A hidden threat. World J Hepatol 2013; 5: 387-92. (Retrospective analysis of 14 Greek HBsAg-negative patients who developed HBV reactivation after immunosuppression identified 10 with anti-HBc alone and 4 with both anti-HBc and anti-HBs before therapy, 11 received rituximab, all developed HBV DNA and ALT elevations 6 to 48 months after starting chemotherapy, 2 developed chronic hepatitis B, 3 developed acute liver failure and 2 died). 23898372
Huang YH, Hsiao LT, Hong YC, Chiou TJ, Yu YB, Gau JP, Liu CY, et al. Randomized controlled trial of entecavir prophylaxis for rituximab-associated hepatitis B virus reactivation in patients with lymphoma and resolved hepatitis B. J Clin Oncol 2013; 31: 2765-72. (Among 80 Chinese patients with lymphoma and anti-HBc without HBsAg in serum, 41 received entecavir and 39 were monitored during rituximab based chemotherapy; reactivation of HBV occurred in 2% on entecavir [1 patient after stopping prophylaxis] versus 18% of controls; while HBsAg reverse seroconversion occurred in 0% on entecavir and 10% of controls, only 1 patient developed hepatitis and none had acute liver failure). 23775967
Kusumoto S, Tanaka Y, Mizokami M, Ueda R. Is antiviral prophylaxis necessary to prevent hepatitis B virus (HBV) reactivation in patients with HBV-resolved infection receiving rituximab-containing chemotherapy? J Clin Oncol 2013; 31: 4480. (Letter in response to Huang [2013] suggesting that monthly monitoring and early intervention with antiviral therapy may be a more cost effective means of dealing with HBV reactivation). 24220561
Oh MJ, Lee HJ. A study of hepatitis B virus reactivation associated with rituximab therapy in real-world clinical practice: a single-center experience. Clin Mol Hepatol 2013; 19: 51-9. (Retrospective analysis of 79 patients treated with rituximab found HBV reactivation in 4 of 12 patients with HBsAg [3 despite prophylaxis with lamivudine], and 2 of 67 [3%] with anti-HBc without HBsAg, both of whom died of acute liver failure). 23593610
Dong HJ, Ni LN, Sheng GF, Song HL, Xu JZ, Ling Y. Risk of hepatitis B virus (HBV) reactivation in non-Hodgkin lymphoma patients receiving rituximab-chemotherapy: a meta-analysis. J Clin Virol 2013; 57: 209-14. (Metaanalysis of 9 studies of reactivation of HBV in patients with non-Hodgkin lymphoma after chemotherapy found increased relative risk with rituximab [1.6 in HBsAg-positive and 5.5 in HBsAg-negative, anti-HBc-positive patients] compared to standard chemotherapy without rituximab). 23562041
Droz N, Gilardin L, Cacoub P, Berenbaum F, Wendling D, Godeau B, Piette AM, et al. Kinetic profiles and management of hepatitis B virus reactivation in patients with immune-mediated inflammatory diseases. Arthritis Care Res (Hoboken) 2013; 65: 1504-14. (Analysis of 35 cases of HBV reactivation in French patients with immune mediated diseases [23 with HBsAg; 12 with anti-HBc without HBsAg], arising 2 weeks to 7 years after starting therapy [86% on corticosteroids, 20% anti-TNF, 31% methotrexate, 11% rituximab], of whom 89% were symptomatic, but none developed acute liver failure or died from liver disease). 23436730
Feeney SA, McCaughey C, Watt AP, Agnaf MR, McDougall N, Wend UC, Gerlich WH et al. Reactivation of occult hepatitis B virus infection following cytotoxic lymphoma therapy in an anti-HBc negative patient. J Med Virol 2013; 85: 597-601. (71 year old man with lymphoma and no detectable HBsAg or anti-HBc developed reactivation of HBV with HBsAg and rising levels of HBV DNA 6 months after finishing a series of courses of rituximab, ultimately responding to tenofovir therapy, but never developing anti-HBc; molecular sequencing revealing an unusual genotype [D4] perhaps acquired in New Guinea). 23359331
Kavcic M, Fisher BT, Seif AE, Li Y, Huang YS, Walker D, Aplenc R. Leveraging administrative data to monitor rituximab use in 2875 patients at 42 freestanding children's hospitals across the United States. J Pediatr 2013; 162: 1252-8, 1258.e1. (In a retrospective analysis of 2875 children treated with rituximab for varying conditions in 42 US childrens hospitals, 6% developed sepsis, but only one had a discharge diagnosis of hepatitis B). 23269206
Wang YH, Fan L, Wang L, Zhang R, Xu J, Fang C, Li JY, et al. Efficacy of prophylactic lamivudine to prevent hepatitis B virus reactivation in B-cell lymphoma treated with rituximab-containing chemotherapy. Support Care Cancer 2013; 21: 1265-71. (In a retrospective analysis of 69 patients with lymphoma given prophylaxis with lamivudine during rituximab based chemotherapy, 1 of 38 with HBsAg, but none of 31 with anti-HBc without HBsAg, developed HBV reactivation; the one case being associated with lamivudine resistant HBV mutation and was anicteric, mild [peak ALT 278 U/L] and resolved with adefovir therapy). 23151650
Mitroulis I, Hatzara C, Kandili A, Hadziyannis E, Vassilopoulos D. Long-term safety of rituximab in patients with rheumatic diseases and chronic or resolved hepatitis B virus infection. Ann Rheum Dis 2013; 72: 308-10. (Among 41 patients with rheumatic diseases who were treated with rituximab, 2 were HBsAg positive and received antiviral prophylaxis and 19 had anti-HBc without HBsAg and were monitored on no prophylaxis; no patient developed HBV reactivation and anti-HBs titers were stable). 22930597
Tonziello G, Pisaturo M, Sica A, Ferrara MG, Sagnelli C, Pasquale G, Sagnelli E, et al. Transient reactivation of occult hepatitis B virus infection despite lamivudine prophylaxis in a patient treated for non-Hodgkin lymphoma. Infection 2013; 41: 225-9. (80 year old woman with non-Hodgkin lymphoma and anti-HBc without HBsAg developed asymptomatic reactivation of HBV 18 months after stopping CHOP-rituximab and 6 months after stopping lamivudine [bilirubin and ALT normal, HBsAg positive and HBV DNA 8000 IU/mL], resolving without therapy within one month). 22855434
Liu CY, Chandrasekar PH, Masood A, Schiffer CA. Adherence to hepatitis B screening and prophylactic lamivudine for prevention of rituximab-associated hepatitis B reactivation. J Oncol Pharm Pract 2013; 19: 18-23. (Among 280 patients who received rituximab during an 18 month period at a single US medical center, screening for HBV markers was done on 84% of cancer and 58% of non-cancer patients; only one person was found to have HBsAg and he developed severe reactivation arising 6 months after rituximab chemotherapy despite lamivudine therapy [bilirubin 28.2 mg/dL, ALT 777 U/L, HBV DNA 2180 IU/mL], recovering after switching to tenofovir therapy). 22635416
Chew E, Thursky K, Seymour JF. Very late onset hepatitis-B virus reactivation following rituximab despite lamivudine prophylaxis: the need for continued vigilance. Leuk Lymphoma 2014; 55: 938-9. (64 year old man with HBsAg [without HBV DNA and with normal enzymes] and Waldenstrom macroglobulinemia received prophylaxis with lamivudine during and for 12 months after a 2 year course of chlorambucil and rituximab, but developed reactivation of hepatitis B 6 months later [ALT 2260 U/L, HBV DNA 28,812 IU/mL], resolving rapidly with tenofovir therapy). 23772645
Tamori A, Hino M, Kawamura E, Fujii H, Uchida-Kobayashi S, Morikawa H, Nakamae H, et al. A prospective long-term study of hepatitis B virus reactivation in patients with hematologic malignancy. J Gastroenterol Hepatol 2014; 29: 1715-21. (Among patients with anti-HBc without HBsAg not receiving prophylaxis, reactivation of HBV occurred in 26% of 19 patients undergoing HCT [onset at 9-36 months] and 10% of 30 patients given rituximab based chemotherapy [onset after 2-10 months], all of whom had anti-HBs titers below 200 mIU/mL before therapy and all of whom were successfully treated with entecavir). 24730465
Martin ST, Cardwell SM, Nailor MD, Gabardi S. Hepatitis B reactivation and rituximab: a new boxed warning and considerations for solid organ transplantation. Am J Transplant 2014; 14: 788-96. (Commentary on the boxed warning for rituximab published by the FDA in September 2013, based upon 109 spontaneous reports of fatal HBV reactivation, questioning the need for prophylaxis in patients undergoing solid organ transplant who typically receive a single dose of rituximab and in whom there have been few reports of reactivation). 24592928
Mikulska M, Nicolini L, Signori A, Rivoli G, Del Bono V, Raiola AM, Di Grazia C, et al. Hepatitis B reactivation in HBsAg-negative/HBcAb-positive allogeneic haematopoietic stem cell transplant recipients: risk factors and outcome. Clin Microbiol Infect 2014; 20: 694-701. (Among 754 patients undergoing hematopoietic cell transplantation, 14 patients developed HBV reactivation, occurring only among the 137 who had anti-HBc without HBsAg before transplant at a rate of 2% at one year, rising to 26% at 7 years; risk factors included lack of HBV immunity in the donor and length of therapy with cyclosporine). 24575948
Ronan BA, Agrwal N, Carey EJ, De Petris G, Kusne S, Seville MT, Blair JE, et al. Fulminant hepatitis due to human adenovirus. Infection 2014; 42: 105-11. (70 year old woman with CLL treated with fludarabine and rituximab developed fever and lymphopenia 3 months after stopping treatment [peak bilirubin 5.4 mg/dL, ALT 1699 U/L, Alk P 282 U/L], dying of multiorgan failure on day 13, liver biopsy showing adenoviral positive viral inclusions). 23979854
Yang F, Zhu HL, He C, Li JJ, Xiang B, Cui X, Huang J, et al. Effect of antiviral prophylaxis strategy for chemotherapy-associated hepatitis B reactivation in non-Hodgkin's lymphoma patients with hepatitis B virus infection: A retrospective cohort study. Indian J Hematol Blood Transfus 2014; 30: 97-104. (Retrospective analysis of rates of reactivation of HBV among Chinese patients with non-Hodgkin lymphoma treated with chemotherapy found lower rates with antiviral prophylaxis). 24839363
Yazici O, Sendur MA, Aksoy S. Hepatitis C virus reactivation in cancer patients in the era of targeted therapies. World J Gastroenterol 2014; 20: 6716-24. . (Systematic review of studies of HCV reactivation in patients receiving monoclonal antibody and immunomodulatory therapies for cancer found little evidence that hepatitis C is worsened but advised caution regardless). 24944464
Buensalido JA, Chandrasekar PH. Prophylaxis against hepatitis B reactivation among patients with lymphoma receiving rituximab. Expert Rev Anti Infect Ther 2014; 12: 151-4. (Review of guidelines regarding screening for HBV and management of patients with lymphoma receiving rituximab; recommends screening for HBsAg, anti-HBc and anti-HBs, providing prophylaxis with antivirals for patients with HBsAg, and close monitoring of those with anti-HBc without HBsAg applying antiviral therapy if HBV reactivation occurs). 24341369
Huang H, Li X, Zhu J, Ye S, Zhang H, Wang W, Wu X, et al. Entecavir vs lamivudine for prevention of hepatitis B virus reactivation among patients with untreated diffuse large B-cell lymphoma receiving R-CHOP chemotherapy: a randomized clinical trial. JAMA 2014; 312: 2521-30. (Among 121 HBsAg-positive patients with B cell lymphoma treated with rituximab-CHOP given prophylaxis with either entecavir or lamivudine, reactivation of HBV occurred in 4 of 61 [7%] given entecavir, none of whom developed hepatitis and 18 of 60 [30%] given lamivudine, 8 of whom developed HBV related hepatitis, one of which was fatal [arising after lamivudine was stopped]). 25514302
Jo T, Horio K. Severe liver damage and nonallergic bronchitis with eosinophilia in a patient with follicular lymphoma treated with bendamustine plus rituximab. Case Rep Oncol 2014; 7: 497-502. (66 year old woman with lymphoma developed hepatitis and unexplained cough and bronchitis after a single cycle of bendamustine and rituximab [peak bilirubin 6.2 mg/dL, ALT 577 U/L, Alk P 947 U/L, eosinophils 36%], resolving within 2 months with corticosteroid therapy; the role of rituximab vs bendamustine being unclear). 25232317
Tsuji H, Yoshifuji H, Fujii T, Matsuo T, Nakashima R, Imura Y, Yukawa N, et al. Visceral disseminated varicella zoster virusinfection after rituximab treatment for granulomatosis with polyangiitis. Mod Rheumatol 2017: 27: 155-61. (30 year old Japanese woman with granulomatosis with polyangiitis developed rash, fever and abdominal pain 2 months after starting prednisolone and rituximab [bilirubin not given, ALT 484 U/L, INR 1.63, platelets 25,000/uL], dying of disseminated coagulopathy, autopsy showing disseminated VSV infection). 25159158
Salah-Eldin MA, Ebrahim MA, El-Sadda W. Clinical outcome of HCV-positive patients with diffuse large B-cell lymphoma treated with rituximab-based chemotherapy. Ann Hematol 2014; 93: 1903-11. (Among 280 patients with chronic hepatitis C and diffuse large B-cell lymphoma, evidence of liver injury [ALT elevations] arose in 68% those receiving rituximab and 54% receiving chemotherapy without rituximab; ALT elevations >5 times ULN occurring in 27% vs 14%]). 24951125
Viganò M, Mangia G, Lampertico P. Management of patients with overt or resolved hepatitis B virus infection undergoing rituximab therapy. Expert Opin Biol Ther 2014; 14: 1019-31. (Review and expert recommendations on the use of antiviral agents as prophylaxis against reactivation during therapy with rituximab). 24909454
Kusumoto S, Tanaka Y, Suzuki R, Watanabe T, Nakata M, Takasaki H, Fukushima N, et al. Monitoring of hepatitis B virus (HBV) DNA and risk of HBV reactivation in B-cell lymphoma: a prospective observational study. Clin Infect Dis 2015; 61: 719-29. (Among 223 patients with B cell lymphoma who had anti-HBc and/or anti-HBs without HBsAg in serum, monthly monitoring for HBV DNA during rituximab based chemotherapy, 21 developed rising levels of HBV DNA [8.3% at 1.5 years], generally within 2-6 months, but 2 after 1 year; all had anti-HBc at baseline and all responded to entecavir therapy with rapid loss of HBV DNA and none developed hepatitis). 25935551
Hua Q, Zhu Y, Liu H. Severe and fatal adverse events risk associated with rituximab addition to B-cell non-Hodgkin's lymphoma (B-NHL) chemotherapy: a meta-analysis. J Chemother 2015; 27: 365-70. (Systematic review of controlled trials of rituximab therapy of B cell non-Hodgkin lymphoma for rates of severe adverse events found higher rates of fatal infections, but no significant differences in rates of other severe adverse events, including liver failure). 25872413
Bauer H, Luxembourger C, Gottenberg JE, Fournier S, Abravanel F, Cantagrel A, Chatelus E, et al.; Club Rhumatismes et Inflammation, a section of the French Society of Rheumatology. Outcome of hepatitis E virus infection in patients with inflammatory arthritides treated with immunosuppressants: a French retrospective multicenter study. Medicine (Baltimore) 2015; 94: e675. (Survey of French physicians treating patients with rheumatic diseases identified 23 patients who developed acute hepatitis E while being treated with immunosuppressive regimens [10 on anti-TNF, 4 rituximab, 2 abatacept, 2 tocilizumab and 16 receiving methotrexate, 4 leflunomide and 1 cyclosporine]; all recovered and cleared HEV RNA, some after reduction in immunosuppression and 5 with ribavirin therapy). 25860212
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg? Hepatology 2015; 61: 703-11. (Review of the pathogenesis, clinical course, treatment and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies with particular focus on rituximab and ofatumumab). 25412906
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents [5.5%], but none were attributed to rituximab or to HBV reactivation). 25754159
Hsu PI, Lai KH, Cheng JS, Kao SS, Li YR, Sun WC, Chen WC, et al. Prevention of acute exacerbation of chronic hepatitis B infection in cancer patients receiving chemotherapy in a hepatitis B virus endemic area. Hepatology 2015; 62: 387-96. (Introduction of a computerized entry based alert system improved the frequency of screening of patients for hepatitis B before receiving cancer chemotherapy). 26041578
Cho Y, Yu SJ, Cho EJ, Lee JH, Kim TM, Heo DS, Kim YJ, et al. High titers of anti-HBs prevent rituximab-related viral reactivation in resolved hepatitis B patient with non-Hodgkin's lymphoma. J Med Virol 2016; 88: 1010-7. (Among 108 patients with lymphoma treated with rituximab based chemotherapy who had anti-HBc without HBsAg, reactivation of HBV occurred in none of 51 with high titers of anti-HBs [above 100 IU/mL] compared to 8 of 57 [14%] with low titers, and in none of 39 who received prophylaxis with antiviral agents active against HBV; only 1 of 8 cases was fatal). 26531242
Varisco V, Viganò M, Batticciotto A, Lampertico P, Marchesoni A, Gibertini P, Pellerito R, et al. Low risk of hepatitis B virus reactivation in HBsAg-negative/anti-HBc-positive carriers receiving rituximab for rheumatoid arthritis: a retrospective multicenter Italian study. J Rheumatol 2016; 43: 869-74. (Among 33 patients with rheumatoid arthritis and anti-HBc without HBsAg in serum who received rituximab, 6 had decreases in anti-HBs titers, but only 1 developed low levels of HBV DNA [and was treated with lamviduine], and none developed HBsAg or hepatitis). 26879359
Yilmaz B. Fulminant hepatitis B as a result of reactivation in hematologic patient after rituximab therapy. J Med Virol 2016; 88: 1289-90. (64 year old man with lymphoma with anti-HBc and anti-HBs [titer 88 IU/mL] without HBsAg in serum developed fatal reactivation of HBV 10 months after starting and 2 months after stopping riituximab based chemotherapy). 27249067
Seto WK, Wong DK, Chan TS, Hwang YY, Fung J, Liu KS, Gill H, et al. Association of hepatitis B core-related antigen with hepatitis B virus reactivation in occult viral carriers undergoing high-risk immunosuppressive therapy. Am J Gastroenterol 2016; 111: 1788-95. (Among 124 patients with anti-HBc without HBsAg in serum who received rituximab or underwent hematopoietic cell transplantation, 31 developed reactivation of HBV at a rate of 40% by 2 years, rates being higher in those who tested positive for HBcrAg at baseline [72%] than those who were negative [31%]). 27644733
Hayashi K, Ishigami M, Ishizu Y, Kuzuya T, Honda T, Tachi Y, Ishikawa T, et al. Clinical characteristics and molecular analysis of hepatitis B virus reactivation in hepatitis B surface antigen-negative patients during or after immunosuppressive or cytotoxic chemotherapy. J Gastroenterol 2016; 51: 1081-9. (Clinical description of 30 HBsAg-negative patients who developed reactivation of HBV after cancer or immunosuppressive therapy). 26943169
Castelli R, Ferraris L, Pantaleo G, Lambertenghi Deliliers G, Cicardi M. High rate of hepatitis B viral breakthrough in elderly non-Hodgkin lymphomas patients treated with rituximab based chemotherapy. Dig Liver Dis 2016; 48: 1394-7. (Among 85 elderly patients with non-Hodgkin lymphoma with anti-HBc without HBsAg in serum, 9 [10%] developed reactivation of HBV despite receiving lamivudine prophylaxis, but all responded to treatment with entecavir). 27590841
Torres HA, Hosry J, Mahale P, Economides MP, Jiang Y, Lok AS. Hepatitis C virus reactivation in patients receiving cancer treatment: A prospective observational study. Hepatology 2018; 67: 36-47. (Among 100 patients with chronic hepatitis C and cancer, 23 had a greater than 1 log10 rise in HCV RNA during cancer chemotherapy, 10 of whom had a concurrent flare of hepatitis and 6 of whom required at least transient delay of chemotherapy; rises in HCV RNA were associated with hematologic malignancy, use of rituximab and exposure to high dose corticosteroids). 28653760
Bajema KL, Simonson PD, Greninger AL, Çoruh B, Pottinger PS, Bhattacharya R, Liou IW, et al. Acute liver failure due to Echovirus 9 associated with persistent B-cell depletion from rituximab. Open Forum Infect Dis 2017; 4: ofx174. (19 year old man with nephrotic syndrome treated with corticosteroids and rituximab for 3 years developed relapsing meningoencephalitis followed by acute liver failure, ultimately attributed to Echovirus 9 infection in the setting of B cell depletion and severe hypogammaglobulinemia). 28948184
Buti M, Manzano ML, Morillas RM, García-Retortillo M, Martín L, Prieto M, Gutiérrez ML, et al. Randomized prospective study evaluating tenofovir disoproxil fumarate prophylaxis against hepatitis B virus reactivation in anti-HBc-positive patients with rituximab-based regimens to treat hematologic malignancies: The Preblin study. PLoS One 2017; 12: e0184550. (Among 61 patients with lymphoma treated with rituximab who had anti-HBc without HBsAg in serum, reactivation occurred in none of 33 patients treated with tenofovir vs 3 of 28 [11%] who were closely monitored, 2 of whom were rapidly treated with tenofovir, the third having a mild anicteric hepatitis). 28898281
Wood PR, Caplan L. Drug-induced gastrointestinal and hepatic disease associated with biologics and nonbiologic disease-modifying antirheumatic drugs. Rheum Dis Clin North Am 2018; 44: 29-43. (Review of gastrointestinal and hepatic side effects of antirheumatic drugs mentions the risk of reactivation of hepatitis B with rituximab therapy in susceptible patients). 29149926
Khan ZH, Ilyas K, Ghazanfar H, Khan HH, Hussain Q, Hammad S, Munir A, et al. Fatal fulminant hepatitis from rituximab-induced hepatitis B reactivation in a patient with follicular lymphoma: A case report and a brief review of literature. Cureus 2018; 10: e2257. (79 year old man with lymphoma developed fatal reactivation of HBV two months after completing chemotherapy with rituximab, cyclophosphamide, vincristine and prednisone [bilirubin 29.3 mg/dL, ALT 2122 U/L, INR 5.9, HBsAg and HBeAg positive, HBV DNA 4.53 milion IU/mL]). 29725560
Kelling M, Sokol L, Dalia S. Hepatitis B reactivation in the treatment of non-Hodgkin lymphoma. Cancer Control 2018; 25: 1073274818767879. (Review of reactivation of hepatitis B in patients with non-Hodgkin lymphoma recommends screening patients for HBsAg and anti-HBc and giving prophylaxis with entecavir or tenofovir in patients at high risk for reactivation). 29606020
Yeo D, Hossain I, Lim ST, Farid M, Tao M, Quek R, Tang T, et al. Management of hepatitis B reactivation in lymphoma patients on rituximab with past hepatitis B exposure: An observational study. J Oncol Pharm Pract 2018 Jan 1. [Epub ahead of print] (Among 75 patients with anti-HBc without HBsAg who received rituximab based therapy for lymphoma, 3 patients developed reactivation and there was wide variation in the use of antiviral prophylaxis and the degree of monitoring during therapy and in follow up). 29554828

## OTHER REFERENCE LINKS

1. Recent References on Rituximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Rituximab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rituximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rituximab)